# Belantamab Mafodotin

## OVERVIEW

### Introduction

Belantamab mafodotin is a humanized monoclonal antibody conjugate that was given accelerated approval for therapy of relapsed or refractory multiple myeloma in 2020 but was withdrawn in 2022 after failing to demonstrate a significant increase in survival compared to conventional therapies. Belantamab mafodotin has been linked to transient serum enzyme elevations during therapy and has been implicated in at least one case of fatal sinusoidal obstruction syndrome.

### Background

Belantamab (bel an’ ta mab) mafodotin (ma foe doe’ tin) is a humanized monoclonal antibody to the B cell maturation antigen (BCMA) conjugated by a linker sequence to mafodotin, a direct cellular toxin. BCMA is a cell surface receptor that is highly expressed on multiple myeloma cells as well as normal plasma cells and some mature B lymphocytes. Mafodotin, also known as monomethyl auristatin F (MMAF), is a cytotoxic inhibitor of microtubule formation. The monoclonal antibody conjugate binds to and is taken up by BCMA-expressing malignant myeloma cells, and the microtubule inhibitor is released intracellularly by lysosomal protease hydrolysis of the linker sequence. The intracellular mafodotin inhibits microtubule formation causing cell cycle arrest resulting in apoptotic cell death of myeloma cells. This monoclonal antibody conjugate was shown to be effective in inducing remissions in adults with relapsed or refractory multiple myeloma. Belantamab mafodotin was given accelerated approval in 2020 in the United States for treatment of adults with advanced multiple myeloma after failure of at least four prior therapies. Belantamab mafodotin became available as a powder for reconstitution in single dose vials of 100 mg under the brand name Blenrep. The typical recommended dose regimen was 2.5 mg/kg administered by intravenous infusion every 3 weeks until disease progression or unacceptable toxicity. Side effects were common and included ocular toxicity of keratopathy with decreased visual acuity and blurred vision, nausea, abdominal pain, diarrhea, constipation, anorexia, weakness, headache, fatigue, fever, thrombocytopenia, lymphopenia, anemia, neutropenia, and increases in serum creatinine. Less common, but potentially serious side effects included severe infusion reactions, severe myelosuppression and thrombocytopenia, and embryo-fetal toxicity. Belantamab mafodotin should be administered only by physicians and health care providers with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In publications of the registration trials of belantamab mafodotin, serum aminotransferase elevations arose in up to 57% of treated patients, but were above 5 times the upper limit of normal (ULN) in only 2% to 3%, and no patient developed clinically apparent liver injury attributed to therapy. After its approval and more widespread use, a case of fatal sinusoidal obstruction syndrome was reported in an elderly man with extensively treated multiple myeloma after a 9^th^ cycle of belantamab mafodotin. Belantamab mafodotin was withdrawn from availability in 2022 after an ongoing clinical trial found that it did not significantly prolong progression free survival compared to conventional chemotherapy regimens for advanced and refractory multiple myeloma.

Likelihood score: D (possible cause of clinically apparent liver injury most likely due to sinusoidal obstruction syndrome).

### Mechanism of Injury

The causes of the serum enzyme elevations and sinusoidal obstruction syndrome noted during belantamab mafodotin therapy are not known, but are likely due to direct toxicity of the mafodotin conjugate rather than the monoclonal antibody.

### Outcome and Management

The serum aminotransferase elevations that occurred during belantamab mafodotin therapy were generally transient, mild and asymptomatic, and rarely required dose modification or delay in therapy. The product label for belantamab mafodotin did not recommend routine monitoring of liver tests. Serum aminotransferase elevations above 5 times the upper limit of normal, if detected, should lead to more careful monitoring and suspension of further infusions, at least until enzyme levels return to normal or near normal values. Elevations above 20 times the ULN or any elevation accompanied by jaundice or symptoms or any indications of sinusoidal obstruction syndrome should lead to prompt and permanent discontinuation.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Belantamab Mafodotin – Blenrep®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Belantamab%20Mafodotin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Belantamab Mafodotin | 2050232-20-5 (https://pubchem.ncbi.nlm.nih.gov/compound/Mafodotin) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761158Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline review of approved drugs; analysis of belantamab mafodotin was taken down in October 2023 when the drug was voluntarily withdrawn by the sponsor).
Markham A. Belantamab mafodotin: first approval. Drugs. 2020;80:1607-1613. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of belantamab mafodotin, mentions that serum AST elevations occurred in 57% and alkaline phosphatase elevations in 26% of patients, but does not mention hepatotoxicity or jaundice). 32936437
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector-based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload], including nine that are FDA approved and six others in pivotal trials). 32937862
Lonial S, Lee HC, Badros A, Trudel S, Nooka AK, Chari A, Abdallah AO, et al. Belantamab mafodotin for relapsed or refractory multiple myeloma (DREAMM-2): a two-arm, randomised, open-label, phase 2 study. Lancet Oncol. 2020;21:207-221. (Among 196 patients with relapsed or refractory multiple myeloma and disease progression despite 3 or more lines of therapy who were treated with open-label belantamab mafodotin in a dose of 2.5 or 3.4 mg/kg intravenously every 3 weeks, the overall response rates were 31% and 34% and serious adverse events were slightly more common with the higher dose [40% vs 47%] as were ALT elevations [20% vs 24%, of which 2% vs 6% were ≥ 5 times ULN] and alkaline phosphatase elevations [8% vs 12%]). 31859245
Lonial S, Lee HC, Badros A, Trudel S, Nooka AK, Chari A, Abdallah AO, et al. Longer term outcomes with single-agent belantamab mafodotin in patients with relapsed or refractory multiple myeloma: 13-month follow-up from the pivotal DREAMM-2 study. Cancer. 2021;127:4198-4212. (Continued follow up in the DREAMM-2 study [Lonial 2020] demonstrated that responses were generally maintained and there were no new adverse events, AST elevations occurred in 21% of subjects receiving 2.5 mg/kg of belantamab mafodotin, which were above 5 times ULN in 2% among 196 patients with relapsed or refractory multiple myeloma). 34314018
Baines AC, Ershler R, Kanapuru B, Xu Q, Shen G, Li L, Ma L, et al. FDA approval summary: belantamab mafodotin for patients with relapsed or refractory multiple myeloma. Clin Cancer Res. 2022;28:4629-4633. (Summary of the data on efficacy and safety upon which the FDA gave accelerated approval to belantamab mafodotin as therapy for adults with refractory, advanced multiple myeloma after previous treatment with at least 4 approved regimens; among 291 patients treated in two clinical trials who could be assessed for safety, the adverse event rate was 82%, resulting in drug modification in 54%, dose reductions in 29%, and discontinuations in 8%, with serious adverse events in 71%, including keratopathy in 44%, pneumonia in 7% and sepsis in 5%; no mention of ALT elevations or hepatotoxicity). 35736811
Pessach I, Argyrakopoulou G, Petropoulos F, Rapti I, Danglis F, Trajce E, Chandrinou E. Hepatic Veno-occlusive disease (VOD) in multiple myeloma patient receiving belantamab mafodotin. Leuk Lymphoma. 2023;64:904-906. (74 year old man with advanced, refractory multiple myeloma developed abdominal pain and ascites two weeks after a 9th cycle of belantamab mafodotin, a liver biopsy demonstrating sinusoidal obstruction syndrome, with rapidly progressive course and death from hepatic and multiorgan failure). 36794387
Dimopoulos MA, Hungria VTM, Radinoff A, Delimpasi S, Mikala G, Masszi T, Li J, et al. Efficacy and safety of single-agent belantamab mafodotin versus pomalidomide plus low-dose dexamethasone in patients with relapsed or refractory multiple myeloma (DREAMM-3): a phase 3, open-label, randomised study. Lancet Haematol. 2023;10:e801-e812. (Among 319 adults with refractory or relapsed multiple myeloma treated with either belantamab mafodotin or pomalidomide and dexamethasone, the median progression free survival was 11 vs 7 months and overall survival 21 vs 21 months [neither of which were statistically significantly different], while total and severe adverse event rates were similar, although ocular adverse events were more frequent with belantamab that the pomalidomide regimen; no mention of ALT elevations or hepatotoxicity). 37793771

## OTHER REFERENCE LINKS

Recent References on Belantamab Mafodotin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Belantamab+AND+Mafodotin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Belantamab Mafodotin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Belantamab%20Mafodotin)